# Alpha Interferon

## OVERVIEW

### Introduction

Alpha interferon is a cytokine produced by the innate immune system in response to environmental exposures including viral infections. Alpha interferon in various formulations has been developed as therapy of several forms of cancer and viral infections, but its major use has been as therapy of chronic hepatitis C. Alpha interferon therapy can be associated with transient, mild-to-moderate serum aminotransferase elevations and it has been linked to induction of autoimmune conditions, including autoimmune hepatitis in susceptible persons.

### Background

Alpha interferon (in"' ter feer' on) is a naturally occurring cytokine which is produced by cells of the innate immune system in reaction to viral infection or other environmental stresses. Alpha and beta interferon are considered type I interferons which share antiviral, immunomodulatory as well as antiproliferative effects. The pathways of induction and actions of alpha interferon are quite complex and the antiviral effects are due to induction of multiple intracellular genes. Overall, type I interferons produce an antiviral state inside of cells that decreases viral replication and protects against infection. There are at least 20 copies of the alpha interferon gene in the human genome and multiple formulations of standard recombinant interferon have been produced (alfa-2a, alfa-2b and alfa-con1 or “consensus” interferon). Furthermore, the interferon molecule can be pegylated which causes a prolongation of its half-life, allowing for once weekly as opposed to daily or every other day administration. Because interferon is a protein, it must be given parenterally (usually subcutaneously). Recombinant human interferons were approved for use in cancer in the 1980s, for hepatitis B in 1991 and for hepatitis C in 1992. Peginterferon became available in 2000 and has largely replaced the standard preparations. The typical dose of peginterferon alfa-2a is 180 µg once weekly for 24 or 48 weeks, and for peginterferon alfa-2b 1.5 µg/kg once weekly for 24 to 48 weeks. In chronic hepatitis C, peginterferon is usually given with ribavirin and, more recently, as triple therapy with a protease inhibitor, such as boceprevir, telaprevir, simiprevir or sofosbuvir. Ultimately, oral antiviral regimens are likely to replace peginterferon therapy in chronic hepatitis C. Standard interferon alfa is also approved for use in hairy cell leukemia, malignant melanoma, follicular lymphoma and AIDS-related Kaposi's sarcoma. Local injections of interferon are used to treat condylomata acuminata. Interferon has many side effects which often limit the dose and duration of therapy. The most common side effects include fatigue, muscle aches, headaches, depression, anxiety, bone marrow suppression and rash.

### Hepatotoxicity

Therapy with interferon or peginterferon can be associated with transient and asymptomatic mild-to-moderate serum aminotransferase elevations in up to half of patients. Because the major use of peginterferon is for hepatitis C or in patients with cancer on multiple other medications, serum ALT elevations are often difficult to attribute to the therapy as opposed to the underlying disease. Importantly, however, 1% to 2% of persons receiving alpha interferon for 24 to 48 weeks develop an autoimmune condition, which can be autoimmune hepatitis characterized by development of marked serum aminotransferase activities and jaundice. This side effect usually arises within 1 to 2 months of starting therapy, but can arise later or even after therapy is completed (Case 1). The typical pattern of serum elevations is hepatocellular, and most but not all patients develop or have preexisting autoantibodies such as antinuclear antibody (ANA) or antibody to liver kidney microsomes (anti-LKM) in serum. Instances of primary biliary cirrhosis, sarcoidosis and hepatic granulomas have also been reported after interferon therapy. Finally, interferon therapy of hepatitis B can trigger an acute exacerbation of the hepatitis that is often associated with clearance of HBV DNA and HBeAg and may actually be a favorable prognostic sign suggesting a sustained response (Case 2).

Likelihood score: A (well known cause of clinically apparent liver injury).

### Mechanism of Injury

Interferon has diverse effects on multiple cell types. The autoimmune hepatitis-like syndrome that has been attributed to interferon therapy appears to occur in patients who are predisposed to autoimmune diseases, and is probably due to the immunomodulatory effects of alpha interferon in increasing cell surface display of HLA antigens and in affecting CD4 and CD8+ T cell activity. Alpha interferon therapy can cause an acute exacerbation of autoimmune disease and some instances of an acute hepatitis-like syndrome developing on interferon therapy may represent an exacerbation of autoimmune hepatitis that coexisted with or was mistaken for chronic hepatitis B or C.

### Outcome and Management

The serum aminotransferase abnormalities that arise during interferon therapy are usually asymptomatic and self-limited and rarely require dose modification. In contrast, the autoimmune hepatitis-like syndrome induced by interferon calls for prompt discontinuation of therapy. In most instances, the condition improves or resolves with stopping therapy, but instances of self-perpetuating autoimmune hepatic diseases (sarcoidosis, autoimmune hepatitis, primary biliary cirrhosis) have been reported. Patients with autoimmune hepatitis due to interferon may require corticosteroid or immunosuppressive therapy, which appears to ameliorate the course of injury and may be required long term. Several cases of acute liver failure and cases of chronic autoimmune hepatitis triggered by interferon therapy have been reported, but treatment has not been associated with chronic vanishing bile duct syndrome.

Related biological agents include beta interferon, gamma interferon, interleukin 2.

Agents active against hepatitis C include alpha interferon, peginterferon, boceprevir, ribavirin, simeprevir, sofosbuvir, telaprevir.

Drug Class: Antiviral Agents, Hepatitis C Agents

## CASE REPORTS

### Case 1. Induction of autoimmune hepatitis by a course of peginterferon and ribavirin for chronic hepatitis C.

[NIH Patient #P40]

A 52 year old woman with chronic hepatitis C developed sudden worsening of disease and jaundice 4 weeks after starting peginterferon therapy. She was known to have chronic hepatitis C for 12 years when she was found to have elevations in serum aminotransferase levels and antibody to hepatitis C in serum. She was largely asymptomatic and had no other medical problems. The source of hepatitis C was believed to be blood transfusions after Caesarian section 25 years previously. She had mild chronic hepatitis on liver biopsy and portal fibrosis (2+ fibrosis on a scale of 0 to 6+). HCV RNA levels ranged from 1 to 2 million IU/mL and HCV genotype was 1b. She was started on peginterferon alfa-2a in a dose of 180 µg weekly and ribavirin (1200 mg daily) was added 4 weeks later. With therapy, her serum levels of HCV RNA fell rapidly (Table). Serum aminotransferase levels, however, started to rise and were above 1000 U/L by week four. By week five she was jaundiced and both peginterferon and ribavirin were stopped. Serum ANA was negative, but SMA was weakly positive (1:40) and anti-LKM was present. IgM anti-HAV, HBsAg, anti-HBc and anti-HDV were negative. Ultrasound showed no evidence of biliary obstruction. Immunoglobin levels were elevated before therapy and had risen further (IgG 2130 to 2910 mg/dL). Jaundice worsened for a week and prednisone (20 mg daily) was started, whereupon both bilirubin and aminotransferase levels began to improve. Once ALT levels had returned to baseline, prednisone was gradually decreased and then stopped. However, serum ALT and immunoglobulin levels began to rise again and prednisone was reintroduced. After serum ALT levels had again fallen, the dose of prednisone was reduced and azathioprine was started (100 mg daily initially and later 50 mg daily), ultimately allowing for discontinuation of prednisone. Serum aminotransferase levels remained normal on azathioprine alone, but ANA became weakly positive. HLA typing showed A33, B42, B53 and DRB 3.

#### Key Points

Medication: | Peginterferon alfa-2a (180 µg/week)
Pattern: | Hepatocellular (R=20)
Severity: | 3+ (jaundice requiring hospitalization and intervention)
Latency: | 5 weeks to onset of jaundice
Recovery: | Incomplete, chronic autoimmune hepatitis requiring long term therapy
Other medications: | Ribavirin

#### Laboratory Values

Time After Starting | Therapy | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | HCV RNA (IU/mL) | Other
- 8 weeks | | 204 | 91 | -0.9 | 1,420,000 | IgG 2130 mg/dL, ANA neg
- 4 weeks | | 185 | 83 | 0.7 | 2,890,000
Peginterferon (180 µg/week) started
0 | | 203 | 92 | 0.4 | 2,130,000
2 weeks | Peginterferon | 329 | 102 | 0.4 | 587,000
4 weeks | Peginterferon | 1093 | 133 | 0.9 | <100
6 weeks | Peg & Rbv | 1002 | 162 | 8.0 | <10 | IgG 2910, ANA neg, LKM pos
7 weeks | None | 1206 | 147 | 15.8 | <10
Prednisone started (20 mg daily)
8 weeks | Pred 20 mg | 1110 | 136 | 5.3 | <10
10 weeks | Pred 20 mg | 784 | 117 | 2.1 | 212,000
5 mo | Pred 10 mg | 165 | 66 | 0.6
9 mo | Pred 5 mg | 134 | 85 | 0.6 | 1,350,000
Prednisone stopped
18 mo | None | 216 | 98 | 0.4 | 3,645,000
25 mo | None | 348 | 121 | 0.8 | 2,656,800
Prednisone (20 mg daily) restarted with azathioprine
29 mo | Pred 20 & Az | 54 | 100 | 0.8 | 7,452,000
40 mo | Pred 5 & Az | 30 | 62 | 0.4
Prednisone stopped and azathioprine continued (100 mg daily)
4 years | Az 100 | 26 | 86 | 0.8 | 11,529,000
5 years | Az 100 | 35 | 118 | 0.5 | 20,682,000
10 years | Az 50 | 38 | 47 | 0.4 | 28,300,000
Normal Values | | <42 | <115 | <1.2

Abbreviations: Peg, peginterferon; Rbv, ribavirin; Pred, prednisone; Az, azathioprine.

#### Comment

A patient with chronic hepatitis C and hyperglobulinemia developed worsening of serum aminotransferase levels and jaundice after 4-5 weeks of peginterferon therapy. Because of the autoimmune features and the lack of immediate improvement on stopping peginterferon, prednisone was started. Prednisone was gradually reduced in dose and discontinued 9 months later, but serum aminotransferases rose and hyperglobulinemia reappeared. Ultimately, the combination of prednisone and azathioprine led to control of the disease and normal serum aminotransferase levels. After a year of tapering doses of prednisone, it was stopped and she was maintained on azathioprine alone, with normal serum aminotransferase levels despite high levels of HCV RNA. One interpretation of the events is that she had autoimmune hepatitis even before interferon therapy, and the HCV infection was benign and not the cause of the serum aminotransferase elevations. Peginterferon is known to be immunomodulatory and capable of causing an exacerbation or flare of autoimmune conditions. The presence of a serious autoimmune disease is a relative contraindication to use of interferon.

### Case 2. Acute flare of hepatitis B during alpha interferon therapy.

[NIH Case #T37]

A 47 year old man with chronic hepatitis B was enrolled in a clinical trial of alpha interferon therapy in early 1989. He was known to have had HBsAg and HBeAg in serum for the previous 8 years and had persistent elevations in serum aminotransferase levels. He was symptomatic with mild fatigue with occasional periods of nausea, but denied dark urine, jaundice, itching, weight loss or abdominal swelling. Physical examination was unrevealing. A liver biopsy showed chronic hepatitis with marked activity (histology activity score=11 of a possible 18) and bridging hepatic fibrosis (Ishak fibrosis score 4 of a possible 6). He was started on interferon alfa-2b in a dose of 10 million units (MU) three times weekly. When he returned after 4 weeks of therapy, he complained of fatigue, nausea and jaundice and serum bilirubin was 10.4 mg/dL. However, HBV DNA was no longer detectable (lower limit of detection was 160,000 copies/mL). The dose of interferon was decreased to 5 MU three times weekly. His symptoms resolved rapidly and, in follow up, serum bilirubin and aminotransferase levels fell into the normal range. He became HBeAg as well as HBsAg negative, but did not develop anti-HBs. During long term follow up, he remained HBsAg negative, with normal serum aminotransferase levels and no detectable HBV DNA.

#### Key Points

Medication: | Interferon alpha (10 MU three times weekly)
Pattern: | Hepatocellular
Severity: | 2+ (jaundice and symptoms)
Latency: | 4 weeks
Recovery: | 12 weeks
Other medications: | None

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | HBV DNA (copies/mL) | Other
Pre | | 197 | 110 | 0.8 | 234,000 | HBsAg positive
0 | | 334 | 105 | 0.9 | 5,254,000 | HBeAg positive
Interferon alfa-2b (10 MU thrice weekly) started
4 weeks | | 1037 | 148 | 5.9 | <160,000
8 weeks | | 151 | 140 | 2.3 | <160,000 | HBeAg negative
12 weeks | | 93 | 119 | 1.7 | <160,000 | HBsAg negative
16 weeks | 0 | 44 | 110 | 0.7
Interferon alfa-2b stopped
20 weeks | 4 weeks | 36 | 96 | 0.6
24 weeks | 8 weeks | 25 | 93 | 0.7
1 year | 8 months | 14 | 66 | 0.3 | Undetectable
5 years | 5 years | 13 | 112 | 0.7 | None | HBsAg negative
Normal Values | | <42 | <115 | <1.2

#### Comment

A patient with HBeAg positive chronic hepatitis B developed an acute flare of disease and jaundice within 4 weeks of starting interferon alfa therapy. The flare was accompanied by a dramatic decrease in HBV DNA levels, followed by clearance of both HBeAg and HBsAg and resolution of the chronic hepatitis. Thus, the liver injury reflected clearance of hepatitis B virus rather than direct hepatotoxicity of interferon. An acute flare of hepatitis is often considered a favorable prognostic sign during the therapy of chronic hepatitis B presaging loss of HBeAg and, sometimes, loss of HBsAg as well. The initial HBV DNA testing was based upon a relatively insensitive method which had a lower limit of detection of 160,000 copies/mL. In follow up, polymerase chain reaction based assays for HBV DNA were used that had a lower limit of detection of 500 copies/mL.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Alpha Interferon – Avonex®

Peginterferon – Pegintron®

DRUG CLASS

Antiviral Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Interferon)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Alpha Interferon | 76543-88-9 | C860-H1353-N227-O255-S9 | Not available
Peginterferon | 215647-85-1 | Unspecified | Not available

## ANNOTATED BIBLIOGRAPHY

References updated: 04 May 2018

Zimmerman HJ. Antiviral agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 621-3. (Expert review of antiviral agents and liver injury published in 1999; mentions that the interferons can cause "dose-related hepatic injury in humans").
Núñez M. Hepatotoxicity of antiviral agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 505-18. (Review of hepatotoxicity of antiviral agents mentions the risk of decompensation in patients with pre-existing cirrhosis treated with interferon alfa).
Acosta EP, Flexner C. Antiviral agents (nonretroviral). In, Brunton LL, Chabner KA, Knollman KC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1591-1622. (Textbook of pharmacology and therapeutics).
Jones GJ, Itri LM. Safety and tolerance of recombinant interferon alfa-2a(Roferon-A) in cancer patients. Cancer 1986; 57 (8 Suppl): 1709-15. (Pooled analysis on 1300 patients with cancer in clinical trials using varying doses [often high >12 MU] and regimens [daily or every other day] of alpha interferon reported elevations in ALT in 77%, Alk P in 48% and bilirubin in 31%, but these "were rarely severe or dose limiting" and no reports of hepatitis). 3948143
Quesada JR, Talpaz M, Rios A, Kurzrock R, Gutterman JU. Clinical toxicity of interferons in cancer patients: a review. J Clin Oncol. 1986; 4: 234-43. (Review of side effects of interferon, based partially on experience in treating 800 patients with cancer; ALT elevations occurred in 25-30% on standard and up to 80% with higher doses, peak AST values ranged from 50 to 300 U/L). 2418169
Vento S, Di Perri G, Garofano T, Cosco L, Concia E, Ferraro T, Bassetti D. Hazards of interferon therapy for HBV-seronegative chronic hepatitis. Lancet 1989; 2: 926. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/%202571851) (Two patients, a 49 year old woman and a 17 year old man with chronic hepatitis C had an acute exacerbation of hepatitis during interferon alfa 2b therapy, with symptoms and jaundice arising at 4 and 6 weeks [bilirubin 7.4 and 13.7 mg/dL, ALT 1800 and 2125 U/L, ANA 1:160 and 1:80], both requiring prolonged prednisone therapy).
Mayet WJ, Hess G, Gerken G, Rossol S, Voth R, Manns M, Meyer zum Buschenfelde KH. Treatment of chronic type B hepatitis with recombinant alpha interferon induces autoantibodies nonspecific for autoimmune chronic hepatitis. Hepatology 1989; 10: 24-8. (Among 31 patients treated with interferon alfa for chronic hepatitis B, 27 [87%] developed at least one autoantibody, usually thyroid antibodies, ANA or SMA; none developed clinically apparent autoimmune disease). 2737600
Silva MO, Reddy KR, Jeffers LJ, Hill M, Schiff ER. Interferon-induced chronic active hepatitis? Gastroenterology 1991; 101: 840-2. (54 year old man with chronic hepatitis B and cirrhosis treated with interferon for 4 months became HBV DNA, HBeAg and HBsAg negative, but had persistence of ALT elevations, jaundice and ascites, improving somewhat with prednisone therapy). 1860646
Ruiz-Moreno M, Rua MJ, Carreno V, Quiroga JA, Manns M, Meyer zum Buschenfelde KH. Autoimmune chronic hepatitis type 2 manifested during interferon therapy. J Hepatol 1991; 12: 265-6. (16 year old girl with chronic hepatitis B developed rise in ALT levels after 2 months of interferon therapy, resolving with stopping but recurring with restarting, with rises in anti-LKM and need for prolonged prednisone therapy to control enzyme elevations). 1904895
Marcellin P, Colin F-F, Boyer N, Bernuau J, Degott C, Hirschauer C, Benhamou J-P. Fatal exacerbation of chronic hepatitis B induced by recombinant alpha-interferon. Lancet 1991; 338: 828. (62 year old man with hepatitis B and cirrhosis developed jaundice and ascites during clearance of HBV DNA, 9 weeks after starting interferon [bilirubin 20.5 mg/dL, ALT 2600 U/L], with progressive liver failure and death). 1681203
Durand JM, Kaplanski G, Portal I, Scheiner C, Berland Y, Soubeyrand J. Liver failure due to recombinant alpha interferon. Lancet 1991; 338: 1268-9. (60 year old man developed jaundice 9 months after starting interferon for leukemia [bilirubin 25.3 mg/dL, ALT 1268 U/L, Alk P 230 U/L, no autoantibodies], developing progressive hepatic failure and death). 1682660
Wandl UB, Kloke O, Niederle N. Liver failure due to recombinant alpha interferon for chronic myelogenous leukaemia. Lancet 1992; 339: 123-4. (43 year old woman developed jaundice 6 months after starting interferon for leukemia [bilirubin 14.8 mg/dL, ALT 705 U/L, Alk P 355 U/L, autoantibodies negative]; patient died of hepatic failure 6 weeks later, cirrhosis on autopsy). 1345846
Shindo M, Di Bisceglie AM, Hoofnagle JH. Acute exacerbation of liver disease during interferon alfa therapy for chronic hepatitis C. Gastroenterology 1992; 102 (4 Pt 1): 1406-8. (68 year man with chronic hepatitis C and cirrhosis and positive ANA [1:640] developed abdominal pain and jaundice during 2nd week of interferon therapy, improving with stopping and recurring with retreatment [bilirubin rising from 1.8 to 11.0 mg/dL, ALT 55 to 260 U/L, HCV RNA and ANA levels not changing], improving with prednisone therapy). 1551549
Papo T, Marcellin P, Bernuau J, Durand F, Poynard T, Benhamou JP. Autoimmune chronic hepatitis exacerbated by alpha-interferon. Ann Intern Med. 1992; 116: 51-3. (3 patients, one man and two women, 40, 40 and 42 years old, with autoimmune hepatitis [misdiagnosed initially as hepatitis C] had flares of hepatitis on interferon, with onset of symptoms after 8, 4 and 4 weeks of treatment [bilirubin 15.5 mg/dL in one but evidently normal in the others with peak ALT 1728, 378 and 456 U/L, autoantibodies present], improving with stopping interferon and adding prednisone; all 3 were anti-HCV negative by sensitive and specific assays). 1727095
Janssen HL, Brouwer JT, Nevens F, Sanchez-Tapias JM, Craxi A, Hadziyannis S. Fatal hepatic decompensation associated with interferon alfa. European concerted action on viral hepatitis (Eurohep). BMJ 1993; 306: 107-8. (Survey of European centers identified 9 of 2490 interferon treated patients who developed a severe and fatal worsening of hepatitis with therapy; all had cirrhosis; 7 had HBV, 1 HCV, 1 both; arising at 3-24 weeks on, or 3 and 16 weeks after therapy; with peak AST 9-500 U/L, bilirubin 3.1-40 mg/dL). 8435602
Lindahl K, Weiland O, Schvarcz R. [Report of a case: hepatic failure after treatment with interferon]. Lakartidningen. 1993; 90: 3075-6. Swedish. (22 year old man with diabetes and chronic hepatitis C with cirrhosis developed fatigue and jaundice 6 weeks after starting interferon [bilirubin rising from 0.6 to 26.8 mg/dL, ALT 120 to 1340 U/L and hyperglobulinemia without autoantibodies], progressing to multiorgan failure and death 8 weeks later). 8264269
van der Watt M, Lemmer E, Robson SC. Exacerbation of liver disease during interferon-alpha therapy for chronic hepatitis C. S Afr Med J 1994; 84 (8 Pt 1): 509. (3 cases, 37 year old woman, 12 year old boy and 50 year old man with chronic hepatitis C, 2 with ANA and/or SMA, who worsened on interferon therapy, patients appearing to have both autoimmune hepatitis and hepatitis C). 7825090
D'Amico E, Paroli M, Fratelli V, Palazzi C, Barnaba V, Callea F, Consoli G. Primary biliary cirrhosis induced by interferon-. therapy for hepatitis C virus infection. Dig Dis Sci 1995; 40: 2113-6. (55 year old woman with hepatitis C treated with interferon for 6 months, had relapse thereafter with rising Alk P and ALT and de novo development of AMA, biopsy showing probable primary biliary cirrhosis). 7587775
Propst A, Propst T, Dietze O, Kathrein H, Judmeier G, Vogel W. Development of granulomatous hepatitis during treatment with interferon-alpha 2b. Dig Dis Sci 1995; 40: 2117-8. (Two men, ages 31 and 23, had a rise in ALT after 3-4 months of interferon therapy of hepatitis found to have small, discrete granulomas with giant cells on liver biopsy, not seen before, ALT levels fell after stopping). 7587776
Todros L, Saracco G, Durazzo M, Abate ML, Touscoz G, Scaglione L, Verme G, et al. Efficacy and safety of interferon alfa therapy in chronic hepatitis C with autoantibodies to liver-kidney microsomes. Hepatology 1995; 22: 1374-8. (Among 12 patients with chronic hepatitis C and anti-LKM, the sustained response rate to interferon therapy was 25%, similar to the antibody negative group [19%]; one had flare at 3 months [ALT 426 U/L] without change in anti-LKM titers and resolving upon stopping). 7590650
Styrt B, Freiman JP. Hepatotoxicity of antiviral agents. Gastroenterol Clin North Am 1995; 24: 839-52. (Review of liver toxicity of antiviral agents; interferons can cause minor aminotransferase elevations in patients without hepatitis and can lead to flare of hepatitis B early in the course that can be life threatening in patients with advanced cirrhosis). 8749901
Garcia-Buey L, Garcia-Monzon C, Rodriguez S, Borque MJ, Garcia-Sanchez A, Iglesias R, De Castro M, et al. Latent autoimmune hepatitis triggered during interferon therapy in patients with chronic hepatitis C. Gastroenterology 1995; 108: 1770-7. (Among 144 patients with chronic hepatitis C treated with interferon, 7 women had a flare of liver enzymes on treatment [432-1500 U/L], mild bilirubin elevations [peak 2.4 mg/dL] and autoantibodies [anti-LKM in 3, ANA in 5], 5 responded to immunosuppressive therapy; frequently had autoimmune associated HLA types DR3 and DR4). 7768382
Fattovich G, Giustina G, Favarato S, Ruol A. A survey of adverse events in 11,241 patients with chronic viral hepatitis treated with alfa interferon. J Hepatol. 1996; 24: 38-47. (Retrospective survey of adverse effects among 11,241 patients with chronic viral hepatitis treated with interferon; 4 died of liver failure, 3 with preexisting cirrhosis, decompensation developing after 8-33 weeks; no mention of autoantibodies). 8834023
Maeda T, Onishi S, Muira T, Iwamura S, Tomita A, Saibara T, Yamamoto Y. Exacerbation of primary biliary cirrhosis during interferon-alfa2b therapy for chronic active hepatitis C. Dig Dis Sci 1996; 40: 1226-30. (60 year old woman with chronic hepatitis C [and AMA positivity when tested in retrospect] had improvements in ALT levels during interferon therapy, but rise in Alk P [120 to 210 U/L] and GGT [25 to 150 U/L] after 8 weeks, improving with stopping interferon and adding ursodiol; asymptomatic). 7781437
Hirashima N, Mizokami M, Orito E, Koide T, Itazu I, Kumada K, Sakakibara K, et al. Case report: development of hepatocellular carcinoma in a patient with chronic hepatitis C infection after a complete and sustained response to interferon-alpha. J Gastroenterol Hepatol 1996; 11: 955-8. (Patient with cirrhosis due to HCV infection had a sustained virological response to interferon therapy, but was found to have a 2.5 cm hepatocellular carcinoma one year later). 8912134
Cervoni JP, Degos F, Marcellin P, Erlinger S. Acute hepatitis induced by alpha-interferon, associated with viral clearance, in chronic hepatitis C. J Hepatol 1997; 27: 1113-6. (Among ~900 patients treated with interferon for chronic hepatitis C, one 38 year old man and one 54 year old woman developed symptoms with rise in ALT [652 and 1163 U/L] and bilirubin [19.3 and 2.1 mg/dL] 3 and 5 months after starting interferon alfa and resolving within 2 months of stopping, both patients had sustained loss of HCV RNA and no autoantibodies). 9453439
Veerabagu MP, Finkelstein SD, Rabinovitz M. Granulomatous hepatitis in a patient with chronic hepatitis C treated with interferon-alpha. Dig Dis Sci 1997; 42: 1445-8. (48 year old woman with chronic hepatitis C was found to have prominent granulomas on liver biopsy after 6 months of interferon therapy; granulomas were no longer present on repeat liver biopsy 6 months after stopping interferon). 9246044
Ryan BM, McDonald GS, Pilkington R, Kelleher D. The development of hepatic granulomas following interferon-alpha2b therapy for chronic hepatitis C infection. Eur J Gastroenterol Hepatol 1998; 10: 349-51. (Three patients, 2 women and one man, ages 41, 52 and 23 years, were found to have hepatic granulomas during or shortly after interferon therapy of hepatitis C; granulomas were not present before therapy and were absent in one patient on repeat biopsy 17 months later). 9855053
Crosignani A, Invernizzi P, Ferrari R, Manzin A, Bruno S, Zuin M, Bianchi FB, et al. Exacerbation of chronic hepatitis D during interferon alpha administration. Ital J Gastroenterol Hepatol 1999; 31: 66-9. (Among 7 patients with chronic hepatitis D treated with interferon, 2 developed sudden worsening of disease on therapy [bilirubin 20.4 mg/dL and 16.7 mg/dL, ALT >1000 U/L], and ascites, resolving 2 months after with stopping, both had antibody to basal cell layer [BCLA], which is common with HDV infection). 10091106
Lock G, Reng CM, Graeb C, Anthuber M, Wiedmann KH. Interferon-induced hepatic failure in a patient with hepatitis C. Am J Gastroenterol 1999; 94: 2570-1. (43 year old man with chronic hepatitis C developed rise in ALT [260 U/L] 4 weeks after starting interferon which resolved on stopping, but recurred with restarting with jaundice [bilirubin 10-27 mg/dL] and ALT elevation [1038 U/L] and progressing to acute liver failure and liver transplantation). 10484034
Kraus I, Vitezic D. Acute hepatitis induced by alpha-interferon in a patient with chronic hepatitis C. Can J Gastroenterol 2001; 15: 333-5. (33 year old man with chronic hepatitis C had virologic and biochemical response to interferon, but developed malaise and jaundice after 3 months [bilirubin 16.2 mg/dL, ALT 1075 U/L, Alk P 111 U/L], without autoantibodies, resolving with stopping therapy and had sustained loss of HCV RNA). 11381301
Fried M. Side effects of therapy of hepatitis C and their management. Hepatology 2002; 36 Suppl 1: S237-S244. (Review of side effects of interferon, peginterferon and ribavirin therapy; exacerbation of hepatitis is listed as an uncommon serious adverse event). 12407599
Leclerc S, Myers RP, Moussalli J, Herson S, Poynard T, Benveniste O. Sroidosis and interferon therapy: report of five cases and review of the literature. Eur J Intern Med 2003; 14: 237-43. (Analysis of 5 patients and 23 in literature who developed sarcoidosis [usually pulmonary and skin] on interferon therapy, onset after 1-16 [mean=4] months, all resolved but 5 required prednisone therapy, recurrence with restarting interferon in 5 patients). 12919839
Cholongitas E, Samonakis D, Patch D, Senzolo M, Burroughs AK, Quaglia A, Dhillon A. Induction of autoimmune hepatitis by pegylated interferon in a liver transplant patient with recurrent hepatitis C virus. Transplantation 2006; 81: 488-90. (52 year old man with liver transplant for hepatitis C had flare in disease 5 months after stopping peginterferon [ALT rising to 404 U/L and SMA titers increasing], biopsy showed changes suggestive of autoimmune hepatitis and prednisone therapy led to remission). 16477242
Kontorinis N, Agarwal K, Elhajj N, Fiel MI, Schiano TD. Pegylated interferon-induced immune-mediated hepatitis post-liver transplantation. Liver Transpl. 2006; 12: 827-30. (55 year old man with liver transplant for hepatitis C developed rising ALT levels, SMA positivity and biopsy appearance of autoimmune hepatitis on peginterferon therapy despite HCV RNA becoming negative; patient subsequently improved on azathioprine therapy). 16628699
Akay BN, Ekmekci P, Sanli H, Celik G, Bozdayi M. Cutaneous, pulmonary and hepatic sarcoidosis associated with autoimmune complications during interferon-alpha treatment for hepatitis C virus infection. J Eur Acad Dermatol Venereol 2006; 20: 442-5. (50 year old woman developed skin nodules after 8 months and hypothyroidism after 12 months of interferon therapy, with subsequent finding of cutaneous and pulmonary sarcoidosis and hepatic granulomas; skin lesions and chest x-ray abnormalities resolved spontaneously 12-18 months after stopping interferon). 16643145
Berardi S, Lodato F, Gramenzi A, D'Errico A, Lenzi M, Bontadini A, Morelli MC, et al. High incidence of allograft dysfunction in liver transplanted patients treated with pegylated-interferon alpha-2b and ribavirin for hepatitis C recurrence: possible de novo autoimmune hepatitis? Gut 2007; 56: 237-42. (Among 44 patients with liver transplant for hepatitis C treated with peginterferon for more than 6 months, 9 had abnormal liver tests despite virological response, some of whom appeared to have autoimmune hepatitis, ANA positive in 5, SMA in 2, AMA in 1; 5 subsequently appeared to improve with prednisone therapy). 16798778
Kogure T, Ueno Y, Fukushima K, Nagasaki F, Inoue J, Kakazu E, Matsuda Y, et al. Fulminant hepatic failure in a case of autoimmune hepatitis in hepatitis C during peg-interferon-alpha 2b plus ribavirin treatment. World J Gastroenterol 2007; 13: 4394-7. (27 year old woman with chronic hepatitis C developed rising ALT levels months after starting interferon [bilirubin rising from 0.6 to 5.5 mg/dL, ALT 47 to 280 U/L, Alk P 278 to 571 U/L, presence of ANA [1:160] and anti-LKM and raised IgG], subsequently developed signs of hepatic failure, but improved after stopping interferon and starting prednisone). 17708618
Soriano V, Miralles C, Berdú, Berdun MA, Losada E, Aguirrebenjoa K, Ocampo A, et al.; PRESCO Study Group. Premature treatment discontinuation in HIV/HCV-coinfected patients receiving pegylated interferon plus weight-based ribavirin. Antivir Ther 2007; 12: 469-76. (Among 389 patients with HIV-HCV coinfection treated with peginterferon and ribavirin in Spain, 45% stopped therapy early, 2 developed mitochondrial injury with pancreatitis and lactic acidosis [despite not using didanosine], resolving with stopping therapy). 17668555
Drugs for non-HIV viral infections. Treat Guidel Med Lett 2007; 5: 59-70. (Review of status of non-antiretroviral antiviral agents for prevention and treatment of herpes, varicella-zoster, cytomegalovirus, influenza A and B, and hepatitis B and C; no mention of liver related side effects for interferon or peginterferon). 17565338
Coriat R, Podevin P. Fulminant autoimmune hepatitis after successful interferon treatment in an HIV-HCV co-infected patient. Int J STD AIDS 2008; 19: 208-10. (48 year old woman with HIV-HCV coinfection developed ALT elevations [~300 U/L] 3 months after starting interferon despite sustained loss of HCV RNA; 4 months later, she developed jaundice and rising ALT with ANA and anti-LKM positivity and rapid progression to acute liver failure and death). 18397566
Fiel MI, Shukla D, Saraf N, Xu R, Schiano TD. Development of hepatic granulomas in patients receiving pegylated interferon therapy for recurrent hepatitis C virus post liver transplantation. Transpl Infect Dis 2008; 10: 184-9. (Analysis of liver biopsies done on 820 patients with chronic hepatitis C after liver transplantation; 14 [1.7%] had granulomas [usually small, only one found and lobular in location] in posttransplant, but not pretransplant liver, 9 had received peginterferon including 4 with a sustained response). 17916116
Loquai C, Nashan D, Hensen P, Luger TA, Grabbe S, Sunderkotter C, Schiller M. Safety of pegylated interferon-alpha-2a in adjuvant therapy of intermediate and high-risk melanomas. Eur J Dermatol 2008; 18: 29-35. (18 patients with metastatic melanoma received peginterferon adjuvant therapy for an average of 8 months; ALT elevations occurred in 72%, which were >5 times ULN in 11%, 1 requiring drug discontinuation). 18086586
Di Bisceglie AM, Shiffman ML, Everson GT, Lindsay KL, Everhart JE, Wright EC, Lee WM, et al.; HALT-C Trial Investigators. Prolonged therapy of advanced chronic hepatitis C with low-dose peginterferon. N Engl J Med 2008; 359: 2429-41. (Among 1050 adults with chronic hepatitis C who were nonresponders to a course of peginterferon and ribavirin and were then followed on no treatment or on low dose peginterferon alone for 3.5 years, there were no differences in rates of clinical outcomes between the two groups, but serum ALT levels were lower with peginterferon treatment and there was no evidence of hepatotoxicity). 19052125
Di Bisceglie AM, Stoddard AM, Dienstag JL, Shiffman ML, Seeff LB, Bonkovsky HL, Morishima C, et al.; HALT-C Trial Group. Excess mortality in patients with advanced chronic hepatitis C treated with long-term peginterferon. Hepatology 2011; 53: 1100-8. (Among 1050 adult nonresponders with chronic hepatitis C [Di Bisceglie 2008] who were followed on no treatment or treated for 3.5 years with low dose peginterferon, further follow up showed an excess mortality in peginterferon treated subjects [20% vs 15% at 7 years], but the difference was attributable to non-liver related causes). 21480316
Bruix J, Poynard T, Colombo M, Schiff E, Burak K, Heathcote EJ, Berg T, et al; EPIC3 Study Group. Maintenance therapy with peginterferon alfa-2b does not prevent hepatocellular carcinoma in cirrhotic patients with chronic hepatitis C. Gastroenterology 2011; 140: 1990-9. (Among 626 patients with chronic hepatitis C treated with low dose maintenance peginterferon or followed on no treatment for up to 5 years, there were no differences in time to first liver related complication, hepatocellular carcinoma or death while ALT elevations above 5 times baseline arose in 4 peginterferon treated vs 5 controls [1.3% vs 1.6%]). 21419770
Kowdley KV, Lawitz E, Crespo I, Hassanein T, Davis MN, DeMicco M, Bernstein DE, et al. Sofosbuvir with pegylated interferon alfa-2a and ribavirin for treatment-naïve patients with hepatitis C genotype-1 infection (ATOMIC): an open-label, randomised, multicentre phase 2 trial. Lancet 2013; 381 (9883): 2100-7. (Among 316 previously treated patients with chronic hepatitis C, genotypes 1, 4, 5 or 6, treated with 12 or 24 weeks with sofosbuvir, peginterferon and ribavirin, SVR rates were 87-89%, ALT elevations above 5 times ULN occurred in 4 patients [1%], and 1 patient developed an autoimmune hepatitis, but these abnormalities were attributed to peginterferon). 23499440
Lawitz E, Lalezari JP, Hassanein T, Kowdley KV, Poordad FF, Sheikh AM, Afdhal NH, et al. Sofosbuvir in combination with peginterferon alfa-2a and ribavirin for non-cirrhotic, treatment-naive patients with genotypes 1, 2, and 3 hepatitis C infection: a randomised, double-blind, phase 2 trial. Lancet Infect Dis 2013; 13: 401-8. ( Among 122 previously untreated patients with chronic hepatitis C, genotypes 1, 2 or 3, who received sofosbuvir [200 or 400 mg daily] or placebo for 12 weeks combined with peginterferon and ribavirin for 12 to 28 weeks, SVR rates were 90-92% with sofosbuvir and 58% with placebo; ALT and AST elevations occurred in 5 patients on sofosbuvir within 4 weeks of starting therapy, remaining elevated during treatment and resolving once peginterferon was stopped). 23499158
Hézode C, Fontaine H, Dorival C, Larrey D, Zoulim F, Canva V, de Ledinghen V, et al.; CUPIC Study Group. Triple therapy in treatment-experienced patients with HCV-cirrhosis in a multicentre cohort of the French Early Access Programme(ANRS CO20-CUPIC) - NCT01514890. J Hepatol 2013; 59: 434-41. (Among 497 patients with chronic hepatitis C, genotype 1, and cirrhosis treated in a French early access program with 48 weeks of peginterferon and ribavirin with either boceprevir or telaprevir, serious adverse events occurred in 197 patients [40%], hepatic decompensation in 12 [2.4%], severe infection in 24 [4.8%], and 6 patients died [1.5%], the serious complications typically arising in the first 12 weeks of therapy). 23669289
Antiviral drugs. Treat Guidel Med Lett 2013; 11 (127): 19-30. (Review of status of antiviral agents for prevention and treatment of viral infections including hepatitis B and C; discussion of interferon as therapy of hepatitis B and the combination of peginterferon with ribavirin and a protease inhibitor [telaprevir or boceprevir], including side effects of serum aminotransferase elevations, autoantibody formation and induction of autoimmune chronic hepatitis). 23459414
Everson GT, Terrault NA, Lok AS, Rodrigo del R, Brown RS Jr, Saab S, Shiffman ML, et al; Adult-to-Adult Living Donor Liver Transplantation Cohort Study. A randomized controlled trial of pretransplant antiviral therapy to prevent recurrence of hepatitis C after liver transplantation. Hepatology 2013; 57: 1752-62. (Among 79 patients with advanced chronic hepatitis C awaiting liver transplantation who were treated with peginterferon and ribavirin or observed without treatment, 22% of treated subjects achieved a sustained virologic response, but side effects were frequent and sometimes severe, although rates of liver related adverse events were similar with vs without peginterferon treatment). 22821361
Muir AJ, Arora S, Everson G, Flisiak R, George J, Ghalib R, Gordon SC, et al; EMERGE study group. A randomized phase 2b study of peginterferon lambda-1a for the treatment of chronic HCV infection. J Hepatol 2014; 61: 1238-46. (Among 525 patients with chronic hepatitis C treated with 3 different doses of interferon lambda or standard doses of peginterferon alfa and ribavirin for 24 [genotypes 2 or 3] or 48 weeks [genotypes 1 or 4], response rates were similar in the four groups while ALT elevations above 5 times ULN occurred in 12% treated with peginterferon and 2-22% treated with interferon lambda). 25064437
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 12 were attributed to antiviral agents, but all were antiretroviral agents and no case was attributed to interferon not to the oral direct acting agents used to treat hepatitis B and C). 25754159
Okajima A, Yamaguchi K, Taketani H, Hara T, Ishiba H, Seko Y, Nishimura T, et al. Drug-induced liver injury in a chronic hepatitis C patient treated by peginterferon, ribavirin and simeprevir. Hepatol Res 2015; 45: E156-60. (56 year old man with chronic hepatitis C and multiple nonresponses to therapy had a rapid virologic response to the combination of simeprevir, peginterferon and ribavirin, followed by a flare of disease at week 6 [bilirubin 1.2 mg/dL, ALT 796 U/L, Alk P 233 U/L, INR 0.8], which resolved rapidly with stopping all 3 drugs, the injury attributed to simeprevir). 25581068

## OTHER REFERENCE LINKS

1. Recent References on Interferon: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Interferon/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Interferon: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Interferon)